# Baclofen

## OVERVIEW

### Introduction

Baclofen is a centrally acting muscle relaxant commonly prescribed for spasticity in patients with multiple sclerosis. Baclofen has not been linked to rare instances of mild, self-limited, clinically apparent liver injury.

### Background

Baclofen (bak' loe fen) is a gamma-amino butyric acid (GABA) derivative that acts as an agonist of the GABA B receptor, thereby activating potassium channels and reducing calcium conductance leading to hypotonia and muscle relaxation. Baclofen acts primarily at the level of the spinal cord, inhibiting synaptic reflexes. Baclofen reduces the number and severity of muscle spasms and relieves pain, clonus and muscle rigidity due to spasticity. Baclofen is indicated primarily for treatment of spasticity from spinal cord injuries and multiple sclerosis. It has been used off label as adjunctive therapy to help with alcohol abstinence and withdrawal. Baclofen was approved for use in the United States in 1977 and is widely used with several million prescriptions filled yearly. Baclofen is available in various generic forms as well as under the brand names of Lioresal and Remular in tablets of 10 or 20 mg and in formulations for intrathecal injections of 0.5 mg/mL. The recommended adult dose for spasticity is 10 to 20 mg orally three to four times daily. The dose should be increased and tapered gradually. The most common side effects of baclofen are nausea, drowsiness, confusion, dizziness and fatigue.

### Hepatotoxicity

Limited data are available on the potential hepatotoxicity of baclofen. Among the many clinical trials evaluating the safety and efficacy of baclofen, none mentioned hepatic toxicity or rates of serum ALT elevations occurring during chronic therapy. The product insert starts that 5% of treated patients develop mild serum aminotransferase elevations, but little documentation is available on the significance, severity or duration of these abnormalities. A single case of mild and self-limited hepatitis attirbuted to baclofen has been published. The latency to onset was 3 months, the pattern of injury was hepatocellular, and recovery was rapid and complete, all laboratory tests being normal within a few weeks of stopping.

Likelihood score: D (Possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The apparent absence of significant hepatotoxicity from baclofen may be due to its minimal hepatic metabolism (~15%) and rapid urinary excretion.

### Outcome and Management

The minor ALT elevations associated with chronic baclofen use are usually asymptomatic and transient. Any elevation of greater than 10 times the upper limit of normal or persistence of abnormalities greater than 5 times the upper limit of normal should lead to discontinuation. Cases of clinically apparent liver injury have been self-limited in course and outcome and there have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome associated with its use. There is no reason to suspect cross sensitivity to liver injury among the various muscle relaxants.

Drug Class: Muscle Relaxants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Baclofen – Generic, Lioresal®

DRUG CLASS

Autonomic Agents: Muscle Relaxants, Central

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=baclofen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Baclofen | 1134-47-0 | C10-H12-Cl-N-O2 | Baclofen chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 30 January 2017

Zimmerman HJ. Muscle spasmolytics. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 544-45. (Expert review of hepatotoxicity published in 1999; mentions baclofen has been used for decades, but specific reports of hepatic injury are scanty).
Hudgson P, Weightman D, Cartlidge NE. Clinical trial of baclofen against placebo. Postgrad Med J 1972; 48 (Suppl 5): 37-40. (23 patients treated with baclofen in a placebo controlled trial; central nervous system side effects discussed, but no mention of hepatotoxicity). 4585729
Brogden RN, Speight TM, Avery GS. Baclofen: a preliminary report of its pharmacological properties and therapeutic efficacy in spasticity. Drugs 1974; 8: 1-14. (Review of preliminary studies of baclofen including side effects; does not mention ALT abnormalities or hepatotoxicity). 4154834
Cartlidge NE, Hudgson P, Weightman D. A comparison of baclofen and diazepam in the treatment of spasticity. J Neurol Sci 1974; 23: 17-24. (Controlled trial in 49 patients discusses central nervous system side effects, but does not mention ALT abnormalities or hepatotoxicity). 4850175
Basmajian JV. Lioresal(baclofen) treatment of spasticity in multiple sclerosis. Am J Phys Med 1975; 54: 175-7. (Double-blind cross over trial of placebo vs baclofen for 4 weeks; no mention of hepatotoxicity). 1098477
From A, Heltberg A. A double-blind trial with baclofen (Lioresal) and diazepam in spasticity due to multiple sclerosis. Acta Neurol Scand 1975; 51: 158-66. (Double-blind cross over trial in 17 patients; major side effect was sedation; no mention of ALT elevations or hepatotoxicity). 1090103
Duncan GW, Shahani BT, Young RR. An evaluation of baclofen treatment for certain symptoms in patients with spinal cord lesions. A double-blind, cross-over study. Neurology 1976; 26: 441-6. (Double-blind cross over study in 22 patients; no mention of ALT monitoring or hepatotoxicity). 772461
Milla PJ, Jackson AD. A controlled trial of baclofen in children with cerebral palsy. J Int Med Res 1977; 5: 398-404. (Cross over study of baclofen vs placebo in 20 children; no mention of ALT monitoring or hepatotoxicity). 338390
Sachais BA, Logue JN, Carey MS. Baclofen, a new antispastic drug. A controlled, multicenter trial in patients with multiple sclerosis. Arch Neurol 1977; 34: 422-8. (106 patients given baclofen or placebo for 5 weeks; no laboratory abnormalities found and no mention of hepatotoxicity). 327987
Feldman RG, Kelly-Hayes M, Conomy JP, Foley JM. Baclofen for spasticity in multiple sclerosis. Double-blind cross-over and three-year study. Neurology 1978; 28: 1094-8. (23 patients in a 10 week cross over trial and then given baclofen for 3 years; laboratory tests taken every 3 months showed no abnormality and results make no mention of hepatotoxicity). 362234
Ghose K, Holmes KM, Matthewson K. Complications of baclofen overdosage. Postgrad Med J 1980; 56: 865-7. (Overdose of baclofen led to coma and respiratory failure, but no mention of hepatotoxicity). 7267501
Lipscomb DJ, Meredith TJ. Baclofen overdose. Postgrad Med J 1980; 56: 108-9. (Overdose of baclofen led to coma and respiratory failure, but no mention of hepatotoxicity). 6771749
Smolenski C, Muff S, Smolenski-Kautz S. A double-blind comparative trial of new muscle relaxant, tizanidine (DS 103-282), and baclofen in the treatment of chronic spasticity in multiple sclerosis. Curr Med Res Opin 1981; 7: 374-83. (21 patients were treated with tizanidine or baclofen for 6 weeks; authors make no mention of hepatotoxicity of either drug). 7016449
Chui LK, Pelot D. Hepatic enzyme elevations associated with baclofen. Clin Pharm 1984; 3: 196-7. (Manufacturer reported than <1% of patients on baclofen developed AST elevations, but no case of overt hepatitis was reported; one patient with traumatic quadriplegia and spasticity developed ALT elevations [414 U/L] after 6 weeks of escalating doses of baclofen [80 mg/day] without symptoms or jaundice, which fell to normal with decrease in dose). 6723229
Dapas F, Hartman SF, Martinez L, et al. Baclofen for the treatment of acute low-back syndrome. A double-blind comparison with placebo. Spine 1985; 10: 345-9. (Placebo controlled trial in 200 patients, 98 on baclofen for 6 weeks; no mention of hepatotoxicity). 2931831
Garabedian-Ruffalo SM, Ruffalo RL. Adverse effects secondary to baclofen withdrawal. Drug Intell Clin Pharm 1985; 19: 304-6. (40 year old woman with multiple sclerosis developed spasms and acute psychosis within days of switching from baclofen to amitriptyline; no mention of hepatotoxicity). 3050930
Hulme A, MacLennan WJ, Ritchie RT, John VA, Shotton PA. Baclofen in the elderly stroke patient its side-effects and pharmacokinetics. Eur J Clin Pharmacol 1985; 29: 467-9. (12 elderly patients given baclofen had higher drug levels and more problems with drowsiness, but no mention of hepatotoxicity). 3912190
Roussan M, Terrence C, Fromm G. Baclofen versus diazepam for the treatment of spasticity and long-term follow-up of baclofen therapy. Pharmatherapeutica 1985; 4: 278-84. (18 patients were treated with baclofen for 4 years; authors make no mention of hepatotoxicity). 3906673
Stien R, Nordal HJ, Oftedal SI, Sletteb M. The treatment of spasticity in multiple sclerosis: a double-blind clinical trial of a new anti-spastic drug tizanidine compared with baclofen. Acta Neurol Scand 1987; 75: 190-4. (40 patients given either tizanidine or baclofen for 6 weeks, no changes observed in laboratory tests of liver function or mention made of hepatotoxicity of either drug). 3554879
Bass B, Weinshenker B, Rice GP, et al. Tizanidine versus baclofen in the treatment of spasticity in patients with multiple sclerosis. Can J Neurol Sci 1988; 15: 15-9. (Double-blind cross over study of tizanidine vs baclofen for 5 weeks each and routine laboratory monitoring found no alterations in biochemical test results with either agent). 3345456
Hoogstraten MC, van der Ploeg RJ, vd Burg W, Vreeling A, van Marle S, Minderhoud JM. Tizanidine versus baclofen in the treatment of spasticity in multiple sclerosis patients. Acta Neurol Scand 1988; 77: 224-30. (16 patients treated with tizanidine and baclofen in a cross over study; muscle weakness was more common with baclofen; no mention of laboratory tests or hepatotoxicity). 3376747
Nance PW. A comparison of clonidine, cyproheptadine and baclofen in spastic spinal cord injured patients. J Am Paraplegia Soc 1994; 17: 150-6. (No mention of hepatotoxicity). 7964712
Chen KS, Bullard MJ, Chien YY, Lee SY. Baclofen toxicity in patients with severely impaired renal function. Ann Pharmacother 1997; 31: 1315-20. (Total of 16 instances of baclofen toxicity with depressed consciousness in patients on renal dialysis; no mention of hepatotoxicity). 9391686
Groves L, Shellenberger MK, Davis CS. Tizanidine treatment of spasticity: a meta-analysis of controlled, double-blind, comparative studies with baclofen and diazepam. Adv Ther 1998; 15: 241-51. (Metaanalysis of 10 trials in 270 patients comparing baclofen and tizanidine reported global tolerance, but no mention made of ALT abnormalities or hepatotoxicity). 10186943
Chou R, Peterson K, Helfand M. Comparative efficacy and safety of skeletal muscle relaxants for spasticity and musculoskeletal conditions: a systematic review. J Pain Symptom Manage 2004; 28: 140-75. (Thorough review of the pharmacology, efficacy and side effects of the muscle relaxants). 15276195
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10:1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a specific muscle relaxant). 15390328
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, one was attributed to chlorzoxazone, but none to baclofen). 18955056
Caruso A, Vecchio R, Patti F, Neri S. Drug rash with eosinophilia and systemic signs syndrome in a patient with multiple sclerosis. Clinical Therapeutics 2009; 31: 580-4. (44 year old woman developed drug rash, eosinophilia and jaundice 8 weeks after starting baclofen, mitoxantrone, and piracetam [bilirubin 19.3 mg/dL, ALT 561 U/L, Alk P 705 U/L], resolving within 6 months of stopping; causality assessment implicated mitoxantrone [a toposiomerase inhibitor used to treat multiple sclerosis]). 19393848
Addolorato G, Leggio L. Safety and efficacy of baclofen in the treatment of alcohol-dependent patients. Curr Pharm Des 2010; 16: 2113-7. (Review of trials of baclofen for alcohol withdrawal and dependence; in large numbers of patients with chronic alcoholism and some with significant alcoholic liver disease, baclofen "did not produce any serious or severe side effects"). 20482507
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to baclofen or other muscle relaxants). 20949552
Garbutt JC, Kampov-Polevoy AB, Gallop R, Kalka-Juhl L, Flannery BA. Efficacy and safety of baclofen for alcohol dependence: a randomized, double-blind, placebo-controlled trial. Alcohol Clin Exp Res 2010; 34: 1849-57. (Controlled trial of 12 weeks of baclofen vs placebo in 80 patients with alcohol dependence reported that adverse events were "relatively mild"; no mention of ALT elevations or hepatotoxicity). 20662805
Heydtmann M. Baclofen effect related to liver damage. Alcohol Clin Exp Res 2011; 35: 848. (Letter in response to Garbutt [2010] describing baclofen treatment of 50 patients with alcohol dependence found that those with advanced liver disease responded to lower doses than those with normal liver function). 21303383
Macaigne G, Champagnon N, Harnois F, Cheiab S, Chayette C. Baclofen-induced acute hepatitis in alcohol-dependent patient. Clin Res Hepatol Gastroenterol 2011; 35: 420-1. (46 year old woman with chronic alcoholism and abnormal serum enzymes had worsening of ALT [1.5 to 6.5 times ULN], AST [5.5 to 9 times ULN], with no change in bilirubin or Alk P 2 months after starting baclofen, improving on stopping). 21561828
Brennan JL, Leung JG, Gagliardi JP, Rivelli SK, Muzyk AJ. Clinical effectiveness of baclofen for the treatment of alcohol dependence: a review. Clin Pharmacol 2013; 5: 99-107. (Review of 4 randomized controlled trials of baclofen for alcohol dependence found that data in support of its efficacy were mixed, but that data were consistent regarding its safety; no discussion of ALT elevations or hepatotoxicity). 23869179
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 cases [0.7%] were attributed to muscle relaxants, one of which due to baclofen). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Baclofen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Baclofen/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/12/01/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Baclofen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Baclofen)